# Amoxapine

## OVERVIEW

### Introduction

Amoxapine is a tetracyclic antidepressant used for relief of symptoms of depression caused by either reactive or psychotic depression. Amoxapine has been associated with a low rate of minor serum aminotransferase elevations during treatment and to very rare instances of clinically apparent acute liver injury.

### Background

Amoxapine (a mox' a peen) is a tetracyclic antidepressant belonging to the dibenzoxapine family, similar but somewhat distinct from classical tricyclic antidepressants. Amoxapine has been shown to be effective in both reactive and neurotic depression as well as in major, endogenous depressive disorders. As with other tricyclic antidepressants, the mechanism of action of amoxapine probably involves interruption of norepinephrine transmission. Amoxapine also blocks histaminic and cholinergic receptors which account for its mild sedative effects. Amoxapine was approved for use in the United States in 1992 and is available in tablets of 25, 50, 100 and 150 mg generically and previously under the brand name Ascendin. Recommended doses are 50 mg two or three times daily initially, increasing based upon efficacy and tolerance and changing to once daily dosing, to as high as 300 mg once daily. Common side effects included drowsiness, dizziness, headache, blurred vision, dry mouth, and tremor. Less common and rare side effects include extrapyramidal signs and symptoms, tardive dyskinesia, suicidal ideation, heart arrhythmias and galactorrhea.

### Hepatotoxicity

Liver test abnormalities occur in a small proportion of patients on long term therapy with amoxapine, but elevations are usually mild, asymptomatic and transient, reversing even with continuation of medication. Instances of clinically apparent acute liver injury without jaundice have been reported due to amoxapine, but have been quite rare. Published cases have been mild, anicteric and asymptomatic. The onset of injury was within 1 to 4 weeks of starting, and the pattern of serum enzyme elevations was hepatocellular. Immunoallergic features and autoantibody formation were not present.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which amoxapine causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Amoxapine is metabolized by the liver via the P450 system (predominantly CYP 2D6).

### Outcome and Management

The serum aminotransferase elevations that occur on amoxapine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to amoxapine have been reported. There is no information on cross sensitivity to liver injury between amoxapine and other tricyclic antidepressants, but switching to another class of agents (such as the selective serotonin reuptake inhibitors) is probably prudent.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, Tricyclics: Amitriptyline, Clomipramine, Desipramine, Doxepin, Imipramine, Nortriptyline, Protriptyline, Trimipramine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amoxapine – Generic, Asendin®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amoxapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Amoxapine | 14028-44-5 | C17-H16-Cl-N3-O | Amoxapine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 March 2016

Zimmerman HJ. Tricyclic antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 495-8. (Expert review of hepatotoxicity published in 1999; amoxapine is listed as a tricyclic antidepressant with a very low rate of hepatotoxicity).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of antidepressant hepatotoxicity; amoxapine is listed as a tricyclic antidepressant associated with rare hepatocellular injury and latency of 4-18 days).
O'Donnell JM, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Takahashi R, Sakuma A, Hara T, Kazamatsuri H, Mori A, Saito Y, Murasaki M, et al. Comparison of efficacy of amoxapine and imipramine in a multi-clinic double-blind study using the WHO schedule for a standard assessment of patients with depressive disorders. J Int Med Res 1979; 7: 7-18. (Among 122 Japanese patients with depression treated with amoxapine or imipramine for 3-5 weeks, "abnormal laboratory data indicating any serious dysfunction of internal organs were not observed"). 369926
Rickels K, Case WG, Werblowsky J, Csanalosi I, Schless A, Weise CC. Amoxapine and imipramine in the treatment of depressed outpatients: a controlled study. Am J Psychiatry 1981; 138: 20-4. (Among 158 patients with depression treated with amoxapine, imipramine or placebo for 6 weeks, common side effects were sedation, agitation and dry mouth; no mention of ALT abnormalities or hepatotoxicity). 7446776
Jue SG, Dawson GW, Brogden RN. Amoxapine: a review of its pharmacology and efficacy in depressed states. Drugs 1982; 24: 1-23. (Review of amoxapine safety and efficacy mentions that side effects are generally mild and include anticholinergic effects and rare instances of extrapyramidal side effects and galactorrhea). 7049659
Ban TA, Fujimori M, Petrie WM, Ragheb M, Wilson WH. Systematic studies with amoxapine, a new antidepressant. Int Pharmacopsychiatry 1982; 17: 18-27. (Review of 2 studies of amoxapine comparing once to twice daily dosing suggested that once daily regimens are appropriate for maintenance therapy; no mention of ALT elevations or hepatotoxicity). 7045016
Litovitz TL, Troutman WG. Amoxapine overdose. Seizures and fatalities. JAMA 1983; 250: 1069-71. (Review of cyclic antidepressant overdoses reported to two local poison centers during an 18 month period identified 33 due to amoxapine, 27 suicidal and 4 accidental [pediatric], included 3 who were asymptomatic, 10 with mild drowsiness, 15 with severe toxicity [seizures, coma, tachycardia], and 5 fatalities [hyperthermia and persistent seizures]; no mention of liver test abnormalities or hepatic manifestations). 6876345
Winek CL, Wahba WW, Rozin L. Amoxapine fatalities: three case studies. Forensic Sci Int 1984; 26: 33-8. (Three cases of fatal suicidal overdoses with amoxapine, one patient presenting with stupor and seizures followed by cardiac arrest; no mention of liver abnormalities). 6510852
Gelenberg AJ, Wojcik JD, Lydiard RB, McCormick MG, Falk WE, Hicks RH, Curren FC, Cohen BM. Double-blind comparison of amoxapine and imipramine in the treatment of depressed patients. J Clin Psychiatry 1984; 45: 54-56, 57-9. (In a trial comparing amoxapine with imipramine in 69 patients with major depression, efficacy and safety were similar and side effects were largely due to anticholinergic effects; no mention of ALT elevations or hepatotoxicity). 6363397
Patterson JF. Amoxapine associated with hepatotoxicity. J Clin Psychopharmacol 1987; 7: 50-1. (33 year old man with depression developed elevated liver tests within 4 days of starting amoxapine which worsened for the next 20 days until the drug was stopped, falling to normal within 2 weeks; no specific enzyme or bilirubin results given). 3818992
Leonard BE. Safety of amoxapine. Lancet 1989; 2 (8666): 808. (Letter stressing the neurologic side effects of amoxapine when compared to the tricyclic antidepressants; no mention of liver injury). 2571052
Manapany M, Marchetti B, Bertrand-Lepensec D, Lacroix G, Legré. [Acute cytolytic hepatitis caused by amoxapine]. Gastroenterol Clin Biol 1993; 17: 405-6. (29 year old woman developed nausea and fatigue 18 days after starting amoxapine [bilirubin normal, peak ALT 838 U/L, Alk P 295 U/L], resolving within a month of stopping). 8349085
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants mentions two case reports of cytolytic hepatitis attributed to amoxapine [Patterson 1987, Manapany 1993]). 12904104
Degner D, Grohmann R, Kropp S, RüE, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. (53,042 patients treated with antidepressants in 35 psychiatric hospitals in Germany from 1993-2000 were monitored for adverse drug reactions; increased liver enzymes reported in 16% on tricyclics, 5.5% on SSRIs and 12% of monoamine oxidase inhibitors; amoxapine not specifically mentioned or discussed). 15052513
Kudo K, Inoue H, Ishida T, Tsuji A, Ikeda N. A fatal case of amoxapine poisoning under the influence of chronic use of psychotropic drugs. Leg Med(Tokyo) 2007; 9: 63-7. (43 year old woman found dead with high serum levels of amoxapine, autopsy showing no liver abnormalities). 17150394
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. (Review of drug induced liver injury and summary analysis of reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents; amoxapine is not specifically discussed). 17609231
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents [quetiapine, nefazodone, fluoxetine and venlafaxine], but none were linked to amoxapine). 20949331
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one was attributed to venlafaxine [an SSRI], but none to amoxapine or other tricyclic antidepressants). 23419359
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of drug induced liver injury due to antidepressants; amoxapine is not discussed). 23914755
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; imipramine, desipramine and amitriptyline are discussed, but not amoxapine). 24362450
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to amitriptyline, but none to amoxapine or other tricyclic antidepressants). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and Outcomes of 899 Patients With Drug-Induced Liver Injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases were attributed to antidepressants including one tricyclic [imipramine], but none were attributed to amoxapine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Amoxapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Amoxapine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amoxapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amoxapine)